# Fenoprofen

## OVERVIEW

### Introduction

Fenoprofen is a nonsteroidal antiinflammatory drug (NSAID) used in the treatment of mild-to-moderate pain and arthritis. Fenoprofen has been linked to a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Fenoprofen (fen" oh proe' fen) belongs to the propionic derivative class of NSAIDs similar to ibuprofen, naproxen, ketoprofen, flurbiprofen and oxaprozin. Like other NSAIDs, the anti inflammatory and analgesic properties of fenoprofen are the result of inhibition of tissue cyclooxygenases (Cox-1 and -2) which block the formation of proinflammatory prostaglandins that are important mediators of inflammatory and pain pathways. Fenoprofen has analgesic as well as antipyretic and antiinflammatory activities. Fenoprofen was approved in the United States in 1976 and is still in clinical use. Current indications include chronic joint pain due to osteoarthritis and rheumatoid arthritis, as well as mild-to-moderate acute pain. The recommended dose in adults with pain is 200 mg every 4 to 6 hours. Higher doses are used for chronic arthritis, in the range of 400 to 600 mg 3 or 4 times per day, with a maximum dose of 3,200 mg daily. Fenoprofen is available in the form of capsules or tablets of 200, 300, 400 and 600 mg in both generic and trade formulations (Nalfon) but is available by prescription only. As with other NSAIDs, fenoprofen is generally well tolerated, but side effects can include headache, dizziness, somnolence, gastrointestinal upset, nausea, abdominal discomfort, diarrhea, peripheral edema, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as fenoprofen include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, fetal toxicity, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Prospective studies show that up to 15% of patients taking fenoprofen experience at least transient serum aminotransferase elevations. These elevations are generally transient, mild and asymptomatic, and may resolve even with drug continuation. Marked aminotransferase elevations (above 3 times the upper limit of normal (ULN) occur in less than 1% of patients.

Clinically apparent liver injury with jaundice from fenoprofen is very rare and only individual case reports have been published. The latency to onset has been rapid, often within a few days of starting. The pattern of enzyme elevations has ranged from cholestatic to hepatocellular. Immunoallergic features are present in some cases (low grade fever, rash), but are generally not prominent, and autoantibody formation is rare. Most cases resolve promptly on stopping therapy. Fenoprofen is not mentioned in large case series on drug induced liver injury or acute liver failure. Fenoprofen is not a commonly used NSAID, and the incidence of liver injury with its use is not known, but it is likely to be very rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of fenoprofen hepatotoxicity is not known, but likely to be due to an idiosyncratic reaction to an intermediate of its metabolism. Fenoprofen is extensively metabolized by the liver.

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels to symptomatic hepatitis with or without jaundice. There are no convincing cases of fulminant hepatic failure, chronic hepatitis or vanishing bile duct syndrome attributable to fenoprofen use in the published literature. Patients with fenoprofen induced liver injury should avoid other propionic acid derivatives such as flurbiprofen, ibuprofen, ketoprofen and naproxen.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fenoprofen – Generic, Nalfon®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fenoprofen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fenoprofen | 29679-58-1 | C15-H14-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2025

Abbreviations used: NSAIDs, nonsteroidal antiinflammatory drugs

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; fenoprofen is listed as having a low incidence of hepatotoxicity, only two cases having been described in the literature).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs mentions that a few cases of hepatotoxicity from fenoprofen have been reported).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Stennet DJ, Simonson W, Hall CA. Fenoprofen-induced hepatotoxicity. Am J Hosp Pharm 1978; 35: 901. (68 year old woman developed fatigue and jaundice 7 weeks after starting fenoprofen [bilirubin 3.1 mg/dL, AST 591 U/L, Alk P 20 U/L], resolving within 1 week of stopping). 677132
Andrejak M, Davion T, Gineston JL, Capron JP. Cross hepatotoxicity between non-steroidal anti-inflammatory drugs. Br Med J (Clin Res Ed) 1987; 295 (6591): 180-1. (67 year old woman with chronic arthritis developed jaundice within 2 weeks of starting naproxen [bilirubin 4.6 mg/dL, ALT 450 U/L, Alk P 280 U/L], resolving rapidly upon stopping and recurring within 5 days of subsequently starting fenoprofen [bilirubin not given, ALT ~260 U/L, Alk P ~350 U/L]). 3115366
Kromann-Andersen H, Pedersen A. Reported adverse reactions to and consumption of nonsteroidal anti-inflammatory drugs in Denmark over a 17-year period. Dan Med Bull 1988; 35: 187-92. (Over a 17 year period, 3521 suspected adverse drug reactions due to NSAIDs were reported to a Danish National Registry, 41 of which were attributed to fenoprofen of which 7% were liver related, none of which were fatal). 2966038
Hannequin JR, Doffoel M, Schmutz G. [Hepatitis secondary to current non-steroidal anti-inflammatory agents]. Rev Rhum Mal Osteoartic 1988 Dec; 55(12): 983-8. French. PMID: 3070713 (Review of published literature on hepatotoxicity of NSAIDs mentions 28 cases attributed to ibuprofen, 21 sulindac, 6 piroxicam, 5 diclofenac, 5 indomethacin, 4 naproxen, and 1 fenoprofen; no details given).
Brewer EJ, Giannini EH, Baum J, Bernstein B, Fink CW, Emery HM, Schaller JG. Aspirin and fenoprofen (Nalfon) in the treatment of juvenile rheumatoid arthritis results of the double blind-trial. A segment II study. J Rheumatol 1982; 9: 123-8. (Among 99 children with juvenile rheumatoid arthritis treated with aspirin or fenoprofen for 12 weeks, pain control was similar, but side effects were more with aspirin, ALT elevations arising in 5 children on aspirin [4 required discontinuation], but none on fenoprofen). 7045360
Brooke JW. Fenoprofen therapy in large-joint osteoarthritis: double-blind comparison with aspirin and longterm experience. J Rheumatol 1976; 2: 71-5. (Among 30 patients with osteoarthritis treated with fenoprofen, aspirin or placebo for 6 weeks in a cross over design, aspirin and fenoprofen were superior to placebo in reducing pain and stiffness, and blood chemistry test results did not change; in a subsequent 2 year open label study in 71 patients, one patient with cholecystitis developed transient "hepatitis", but after recovery was able to restart fenoprofen without recurrence). 781234
Blechman WJ, Zane S. Fenoprofen calcium in steroid treated rheumatoid arthritis: efficacy, safety, and steroid-sparing effect. J Rheumatol 1976; 2: 38-42. (Among 27 patients with rheumatoid arthritis treated with fenoprofen or placebo in a 16 week cross over study, "no significant abnormal values were observed in the clinical laboratory examinations"). 781229
McIlwain HH. Fenoprofen calcium versus aspirin in the treatment of acute inflammatory soft-tissue injuries. J Med 1985; 16: 429-38. (Among 95 patients with acute soft tissue injury treated for 3-5 days with either aspirin or fenoprofen, pain control was similar with both agents and adverse events were mild-to-moderate and more frequent with aspirin; no liver related adverse events reported). 3913725
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review of NSAID related liver injury states that fenoprofen and flurbiprofen have rarely been implicated in liver injury, a table lists the pattern of enzyme elevations as being hepatocellular). 2281340
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs overall was ~10 cases per 100,000 patient-years of use; fenoprofen and flurbiprofen are not specifically discussed). 9041931
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases which were matched with 178 controls; 22 cases vs 16 controls had been exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen, and 1 meloxicam, rest to salicylates which were used as frequently in controls as cases; there were no fatalities and cases were more common in women than men; no mention of fenoprofen). 15066135
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years of NSAID use [rate ratio=1.5] and deaths from liver injury occurred in ~1/100,000 patient-years; frequency of injury did not increase with age and was no more common in women than men; in case controlled studies, a higher odds ratio for liver injury was found with sulindac, indomethacin, piroxicam, and diclofenac; no mention of fenoprofen). 15298630
Björnsson Ejerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Survey of all cases of fatal drug induced liver injury from the Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, none were attributed to fenoprofen). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; fenoprofen listed as associated with 27 hepatic reactions from France, but the odds ratio for injury was not elevated and clinical details of injury not given). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verman A, Rothman K. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations. Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Surveys from the UK and USA indicate that ibuprofen, naproxen and diclofenac were the most commonly used NSAIDs; fenoprofen was not among the top 10 agents used). 17086563
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none were attributed to fenoprofen). 18955056
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; no discussion of fenoprofen). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 7 to NSAIDs, including 4 to bromfenac, 2 diclofenac, and 1 etodolac, but none to fenoprofen, ketoprofen, ibuprofen or naproxen). 20949552
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 40 cases, but fenoprofen was not specifically mentioned). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Association Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of serious adverse events reporting to a French pharmacovigilance database found highest cumulative rates for liver related reports for nimesulide [0.15 per million defined daily doses], followed by diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04], and meloxicam [0.03] being significant in case/noncase analyses for nimesulide, diclofenac, and piroxicam only; no mention of fenoprofen). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none were due to fenoprofen). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 cases were attributed to an NSAID including 15 to diclofenac, 3 celecoxib, 3 meloxicam, 2 oxaprozin, 2 etodolac, and 1 each for ibuprofen, sulindac, and valdecoxib, but none for flurbiprofen or fenoprofen). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1231 cases of suspected drug induced liver injury enrolled in a prospective study in the US between 2004 and 2014, 30 [2%] were considered due to an NSAID, including diclofenac [n=16], celecoxib [3], meloxicam [3], etodolac [2], oxaprozin [2], ibuprofen [2], and sulindac [1], while none were attributed to fenoprofen). 26601797
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen, and aspirin and that rare instances of idiosyncratic acute hepatitis attributed to celecoxib have been described; fenoprofen not discussed). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib). 29568654
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to fenoprofen). 38451034
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam; but none to fenoprofen [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Fenoprofen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fenoprofen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fenoprofen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fenoprofen)